# Avapritinib

## OVERVIEW

### Introduction

Avapritinib is a tyrosine kinase receptor inhibitor that targets mutant forms of several genes (KIT, PDGFRA) involved in gastrointestinal stromal tumors which are often found in refractory cases. Serum aminotransferase elevations arise in a small proportion of patients treated with the highest doses of avapritinib, but episodes of clinically apparent liver injury have not been reported with its use.

### Background

Avapritinib (a” va prit’ tin ib) is an orally available, tyrosine kinase inhibitor that targets activation loop mutants of platelet-derived growth factor receptor alpha (PDGFRA), which are often found in patients with resistant gastrointestinal stromal tumors (GIST) and overexpression of KIT which is often present in systemic mastocytosis. Disregulation of these genes results in constitutive kinase activity and uncontrolled growth and proliferation. Avapritinib has potent specificity against gain of function mutants KIT D816V and PDGRA D842V that are resistant to standard tyrosine kinase inhibitors such as imatinib, sunitinib, and regorafenib, the first-, second-, and third-line therapies of GIST. Avapritinib was granted accelerated approval in the United States in 2020 for adults with unresectable to metastatic GIST with documented PDGFRA alpha exon 18 mutations including D842V, the first drug to be approved for this indication. Indications were subsequently expanded to adults with advanced systemic mastocytosis and indolent systemic mastocytosis. Avapritinib is available in tablets of 25, 50, 100, 200 and 300 mg under the brand name Ayvakit. The recommended oral dose varies by indication, being 300 mg once daily for GIST, 200 mg once daily advanced mastocytosis, but only 25 mg once daily for indolent mastocytosis. Therapy should continue until disease progression or unacceptable toxicity. Side effects are dose related, but at the highest dose are common, arising in almost all patients. In preregistration clinical trials, dose interruptions or reductions were needed in 57% and permanent discontinuations in 9% of patients being treated with avapritinib for GIST. Common side effects include anemia, neutropenia, diarrhea, nausea and vomiting, abdominal pain, fatigue, cognitive impairment, dizziness, headache, rash, hair color changes, alopecia, dyspnea, hyperbilirubinemia, weight loss and insomnia. Uncommon but potentially severe adverse events include major cognitive effects, intracranial hemorrhage, photosensitivity, and embryo-fetal toxicity.

### Hepatotoxicity

In the prelicensure clinical trials of avapritinib in patients with GIST harboring the PDGFRA D842V mutation, ALT elevations arose in 20% of patients but were usually self-limited and mild. ALT elevations above 5 times the upper limit of normal (ULN) were uncommon, being found in 1% to 3% of treated patients. In the open label trials supporting the approval of avapritinib, there were no instances of clinically apparent liver injury, hepatic failure or deaths from liver injury. Avapritinib is associated with frequent elevations in serum bilirubin, but the increases are largely indirect and resolve rapidly with discontinuation.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from avapritinib is unknown, but the pattern of abnormalities suggests some degree of direct toxicity. Avapritinib is metabolized in the liver via the cytochrome P450 system, largely CYP 3A4, and is susceptible to drug-drug interactions with agents that inhibit or induce the CYP enzyme reactivity.

### Outcome and Management

The product label for avapritinib does not recommend regular monitoring of liver tests, but if serum aminotransferase levels above 5 times the upper limit of normal are identified, therapy should be held until levels fall into the normal or near normal range, at which point avapritinib therapy can be resumed at the same or a reduced dose as clinically indicated and with continued monitoring. Cross sensitivity to liver injury is uncommon among the antineoplastic small molecule enzyme and receptor inhibitors, but there is no information on shared adverse event sensitivity of avapritinib with other antineoplastic tyrosine kinase receptor inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other Drugs for Gastrointestinal Stromal Tumors: Imatinib, Regorafenib, Sunitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Avapritinib – Ayvakit®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Avapritinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Avapritinib | 1703793-34-3 | C26-H27-F-N10

## ANNOTATED BIBLIOGRAPHY

References updated: 02 September 2023

Abbreviations: GIST, gastrointestinal stromal tumor; KIT, a classical proto-oncogene that encodes a tyrosine kinase receptor that responds to stem cell factor; PDGFRA, platelet-derived growth factor receptor alpha.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss avapritinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/212608Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of avapritinib; describes the adverse events observed in a pooled safety population of 335 patients that included edema in 74%, bilirubin elevations 65%, fatigue 57%, nausea 56%, cognitive impairment 43%, diarrhea 36%, abdominal pain 32%, anemia 49%, hair color change 22%, rash 20%, dyspnea 15%, and ALT elevations 20% which were above 5 times ULN in only 1% [n=3], and there were no discontinuations for ALT elevations and no instances of clinically apparent liver injury, hepatic failure, or fatalities due to liver injury).
Heinrich MC, Jones RL, von Mehren M, Schöffski P, Serrano C, Kang YK, Cassier PA, et al. Avapritinib in advanced PDGFRA D842V-mutant gastrointestinal stromal tumour (NAVIGATOR): a multicentre, open-label, phase 1 trial. Lancet Oncol. 2020;21:935-946. (Among 56 patients with advanced GIST and PDGFRA D842V-mutations treated with avapritinib in a phase 1 open-label trial, the overall response rate was 88% [complete responses in 9%] and almost all patients had adverse events including nausea in 69%, fatigue 41%, anorexia 38%, hair color change e25%, anemia 22%, and neutropenia 19%; no mention of ALT elevations or hepatotoxicity). 32615108
Dhillon S. Avapritinib: first approval. Drugs. 2020;80:433-439. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy and safety of avapritinib shortly after its approval for use in advanced or metastatic GIST in the U.S.; no mention of ALT elevations or hepatotoxicity). 32100250
DeAngelo DJ, Radia DH, George TI, Robinson WA, Quiery AT, Drummond MW, Bose P, Heet al. Safety and efficacy of avapritinib in advanced systemic mastocytosis: the phase 1 EXPLORER trial. Nat Med. 2021;27:2183-2191. (Among 86 patients with advanced systemic mastocytosis enrolled in a phase 1 trial of avapritinib, the overall response rate was 75% and complete remission rate 36% while adverse events were common and included intracranial bleeds in 9 patients, largely in those with preexisting thrombocytopenia [n=7]; no mention of ALT elevations or hepatotoxicity). 34873347
Gotlib J, Reiter A, Radia DH, Deininger MW, George TI, Panse J, Vannucchi AM, et al. Efficacy and safety of avapritinib in advanced systemic mastocytosis: interim analysis of the phase 2 PATHFINDER trial. Nat Med. 2021;27:2192-2199. (Among 62 patients with advanced systemic mastocytosis treated in a phase 2 open-label trial excluding those with platelet count below 50,000/uL, the overall response rate was 75% and side effects were common, but there was only one case with intracranial hemorrhage and no mention of ALT elevations or hepatotoxicity). 34873345
Jones RL, Serrano C, von Mehren M, George S, Heinrich MC, Kang YK, Schöffski P, et al. Avapritinib in unresectable or metastatic PDGFRA D842V-mutant gastrointestinal stromal tumours: Long-term efficacy and safety data from the NAVIGATOR phase I trial. Eur J Cancer. 2021;145:132-142. (Among 250 patients [56 with PDGFRA D824V mutant GIST] treated in phase 1 trials of avapritinib, treatment related adverse events occurred in 98% of patients and included cognitive effects in 46%, intracranial bleeding in 3%; no mention of ALT elevations or hepatotoxicity). 33465704
Avapritinib (Ayvakit) for GIST. Med Lett Drugs Ther. 2021;63(1617):23-24. (Concise review of the mechanism of action, clinical efficacy, adverse effects, drug interactions, and costs of avapritinib shortly after its approval in the U.S. mentions that serious adverse effects occur in 52% of patients and include anemia [9%] and intracranial hemorrhage [1%]; no mention of ALT elevations or hepatotoxicity). 33647006
Reiter A, Schwaab J, DeAngelo DJ, Gotlib J, Deininger MW, Pettit KM, Alvarez-Twose I, et al. Efficacy and safety of avapritinib in previously treated patients with advanced systemic mastocytosis. Blood Adv. 2022;6:5750-5762. (Among 53 patients with advanced systemic mastocytosis treated with avapritinib [200 mg daily] for a median of 15 months, the overall response rate was 71% and adverse events arose in most patients resulting in dose reductions in 57% and including thrombocytopenia [32%], periorbital edema [30%], diarrhea [21%], cognitive disorders [15%], change in hair color [15%], and two instances of subdural hematoma; no mention of ALT elevations or hepatotoxicity). 35640224
Cavazos K, Eswaran S, Maidlow C, Keklik Karadag F, Idilman R, Idilman I, et al. Liver fibrosis and its response to avapritinib in 2 patients with systemic mastocytosis. Blood Adv. 2022;6:5630-5633. (Two patients with advanced systemic mastocytosis were found to have advanced hepatic fibrosis or cirrhosis as shown by elastography and liver biopsy, but had normal liver tests and imaging and tolerated therapy with avapritinib, the hepatic stiffness improving with therapy and without any worsening of liver tests suggesting that avapritinib does not worsen hepatic fibrosis and may improve mastocytosis-associated liver disease). 35839085
Li J, Zhang X, Deng Y, Wu X, Zheng Z, Zhou Y, Cai S, et al. Efficacy and safety of avapritinib in treating unresectable or metastatic gastrointestinal stromal tumors: a phase I/II, open-label, multicenter study. Oncologist. 2023;28:187-e114. (Among 56 Chinese patients with unresectable or metastatic GIST treated with avapritinib [300 mg daily] in phase 1 and 2 clinical trials, the overall response rate was 75% in those with PDGFRA D842V mutations, while adverse events arose in 98% of patients including ALT elevations in 14% which were above 5 times ULN in only 1 patient). 36477870
Pardanani A. Systemic mastocytosis in adults: 2023 update on diagnosis, risk stratification and management. Am J Hematol. 2023;98:1097-1116. (Review of the clinical features, diagnosis, histology, molecular findings, classification and management of systemic mastocytosis including both advanced and indolent forms of the disease condition). 37309222

## OTHER REFERENCE LINKS

Recent References on Avapritinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Avapritinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Avapritinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Avapritinib)